# Zavegepant

## OVERVIEW

### Introduction

Zavegepant is a small molecule inhibitor of the calcitonin gene-related peptide (CGRP) receptor that blocks the action of CGRP, a potent vasodilator believed to play a role in migraine headaches. Zavegepant is provided as a nasal spray and is approved for treatment of acute migraine attacks. In clinical trials, zavegepant was generally well tolerated with only rare instances of transient serum aminotransferase elevations during therapy and with no reported instances of clinically apparent liver injury.

### Background

Zavegepant (za ve’ je pant) is a small molecule inhibitor of the receptor for the calcitonin gene-related peptide (CGRP), which is believed to play a role in the pathogenesis of migraine headaches. CGRP is a potent vasodilator and pain-signaling neurotransmitter that is found throughout the central and peripheral nervous system but is particularly common in trigeminal ganglia. Levels of CGRP in the blood are elevated during episodes of migraine headache, and administration of the peptide can induce migraines in susceptible patients. For this reason, approaches to inhibition of CGRP signaling were developed as potential therapies for migraine, both as preventive therapies to decrease the rate of migraine as well as for treatment of acute attacks. Several monoclonal antibodies that block CGRP or its receptor are approved for use in prevention of migraines and three orally available, small molecule inhibitors of the CGRP receptor (the “gepants”: rimegepant, ubrogepant, and atogepant) are available for treatment or prevention of acute migraine. In contrast, zavegepant is provided in solution as a nasal spray for treatment of acute migraine attacks. In a large randomized, placebo-controlled trial, zavegepant given as a single nasal spray of 10 mg was found to increase the rate of being free from headache pain 2 hours after dosing (24% compared to 15% with placebo). Zavegepant nasal spray was approved for treatment of acute migraine in the United States in 2023 and is available in solution as a nasal spray that delivers 10 mg of Zavegepant under the brand name Zavzpret. The recommended dose is a single nasal spray as soon as possible after onset of migraine with the option to repeat daily and not to exceed 10 mg during any 24-hour period. It is not recommended for prevention of migraine attacks. Zavegepant can be safely given in patients receiving preventive therapy with monoclonal antibodies to CGRP or its receptor. Zavegepant is generally well tolerated with side effects of dysgeusia, nausea, vomiting, and nasal discomfort that are generally transient and mild-to-moderate in severity. Severe adverse events are rare; however, instances of hypersensitivity reactions have been reported.

### Hepatotoxicity

In preregistration, controlled trials of zavegepant in several thousand patients, mild-to-moderate serum aminotransferase elevations arose in a small percentage of patients (1% to 2%) and overall rates were not different from those in placebo recipients. In the controlled trials and subsequently with general use, there have been no reports of clinically apparent liver injury attributed to zavegepant. In contrast, telcagepant, the initial oral CGRP receptor antagonist evaluated as therapy for migraine headaches, was abandoned during development because of several instances of clinically apparent liver injury in recipients that was characterized by marked elevations in serum aminotransferase levels and symptoms of fatigue, nausea and abdominal discomfort arising within 2 to 4 weeks of starting therapy. Such events rapidly resolved with prompt stopping of therapy. Similar episodes have not been reported with zavegepant.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to zavegepant are not known. It is metabolized in the liver largely by CYP 3A4 and is susceptible to drug-drug interactions with agents that induce or inhibit this microsomal enzyme. Lower doses should be used in patients receiving CYP 3A4 inhibitors.

### Outcome and Management

Drug Class: Migraine Headache Agents

Other Small Molecule Inhibitors of CGRP Receptors: Atogepant, Rimegepant, Ubrogepant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zavegepant – Zavzpret®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Zavegepant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Zavegepant | 1337918-83-8 | C36-H46-N8-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 12 January 2025

Abbreviations: CGRP, calcitonin gene-related peptide.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of CGRP receptor antagonists).
FDA. Clinical Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216386Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA clinical scientific review of the zavegepant application reports that ALT elevations arose in 0.1% of 1023 patients treated with intranasal zavegepant vs 0.1% of 1056 placebo recipients, although higher rates were observed with repeat dosing indicating that rare instance of liver injury might arise with overuse).
Ho TW, Connor KM, Zhang Y, Pearlman E, Koppenhaver J, Fan X, Lines C, et al. Randomized controlled trial of the CGRP receptor antagonist telcagepant for migraine prevention. Neurology 2014; 83: 958-66. (Among 660 patients with migraine enrolled in a controlled trial of telcagepant [140 or 280 mg] vs placebo twice daily for 12 weeks, 13 patients on telcagepant developed ALT elevations above 3 times ULN, generally between weeks 4 and 6 of treatment, and in two instances rising to 33 and 39 times ULN accompanied by symptoms but not jaundice leading to prompt discontinuation and to early termination of the trial because of the risk of significant hepatotoxicity). 25107879
Tfelt-Hansen P, Loder E. The Emperor's new gepants: are the effects of the new oral CGRP antagonists clinically meaningful? Headache 2019; 59: 113-7. (Commentary on the relative efficacy of two oral CGRP receptor antagonists, ubrogepant and rimegepant, which show only modest efficacy in acute migraine [therapeutic gain of 5-8%] and only when compared to placebo as compared to well-known effective therapies such as aspirin and other nonsteroidal antiinflammatory agents [8-14%] and the triptans [16-32%]). 30451300
Robbins MS. Diagnosis and management of headache: a review. JAMA 2021; 325: 1874-85. (Review of the diagnosis and management of headache including use of calcitonin gene-related peptide antagonists for acute migraine attacks which has uncommon side effects of dry mouth and dizziness; no mention of ALT elevations or hepatotoxicity). 33974014
Croop R, Madonia J, Stock DA, Thiry A, Forshaw M, Murphy A, Coric V, et al. Zavegepant nasal spray for the acute treatment of migraine: A Phase 2/3 double-blind, randomized, placebo-controlled, dose-ranging trial. Headache. 2022;62:1153-1163. (Among 1588 patients with an acute attack of migraine treated with zavegepant nasal spray [5, 10, or 20 mg] vs placebo, rates of being pain free 2 hours after administration was higher with 10 mg and 20 mg of zavegepant [22.5% and 23.1%] than placebo [15.5%], while adverse events included dysgeusia [13-16% vs 3.5%], nausea [2.7-4.1% vs 0.5%], and nasal discomfort [1.3-5.2% vs 0.2%], and there was “no signal of hepatotoxicity”). 36239038
Woodhead JL, Siler SQ, Howell BA, Watkins PB, Conway C. Comparing the liver safety profiles of 4 next-generation CGRP receptor antagonists to the hepatotoxic CGRP inhibitor telcagepant using quantitative systems toxicology modeling. Toxicol Sci. 2022;188:108-116. (Mechanistic simulation of hepatotoxicity indicated that telcagepant had multiple potential adverse effects on liver function compared to the more recently developed CGRP antagonists, rimegepant, ubrogepant, atogepant, and zavegepant). 35556143
Lipton RB, Croop R, Stock DA, Madonia J, Forshaw M, Lovegren M, Mosher L, et al. Safety, tolerability, and efficacy of zavegepant 10 mg nasal spray for the acute treatment of migraine in the USA: a phase 3, double-blind, randomised, placebo-controlled multicentre trial. Lancet Neurol. 2023;22:209-217. (Among 1269 adults with an acute attack of migraine treated with zavegepant [10 mg] or placebo, rates of being pain free 2 hours after administration were 24% vs 15%, and adverse event rates for dysgeusia was 21% vs 5%, nasal discomfort 4% vs 1%, nausea 3% vs 1%, and “hepatic-related” discontinuations <1% vs 1%, although no participant developed ALT or AST elevations above 3 times ULN). 36804093
Dhillon S. Zavegepant: First approval. Drugs. 2023;83:825-831. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of zavegepant shortly after its approval as therapy of acute migraine headache mentions side effects of taste disorders, nasal discomfort, nausea, and vomiting, and that ALT or AST elevations arose in 2.6% of patients treated in a long term, open label study but there have been no reports of ALT or AST elevations with jaundice or clinically apparent liver injury associated with therapy). 37227596
Drugs for migraine. Med Lett Drugs Ther. 2023;65:89-96. (Concise summary of the relative clinical efficacy, safety, and costs of drugs to treat and to prevent migraine headaches, states that systemic adverse effects are uncommon with use of oral CGRP receptor antagonists, but that nausea and somnolence can occur; no mention of ALT elevations or hepatotoxicity). 37266987
Zavegepant (Zavzpret) for acute treatment of migraine. Med Lett Drugs Ther. 2023;65:116-118. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of zavegepant mentions adverse events of dysgeusia, nausea, nasal discomfort, and vomiting as well as hypersensitivity reactions [facial swelling, urticaria], but does not mention ALT elevations or hepatoxicity). 37460143
Mullin K, Croop R, Mosher L, Fullerton T, Madonia J, Lipton RB. Long-term safety of zavegepant nasal spray for the acute treatment of migraine: A phase 2/3 open-label study. Cephalalgia. 2024;44: 3331024241259456. (Among 603 adults with episodic migraine treated with zavegepant nasal spray [10 mg] for acute episodes of migraine for up to one year, 15 [2.6%] developed ALT or AST elevations above 3 times ULN, 8 of whom [1.3%] discontinued therapy, but none developed jaundice or clinically apparent liver injury). 39210835

## OTHER REFERENCE LINKS

1. Recent References on Zavegepant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Zavegepant+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Zavegepant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zavegepant)